# Atropine

## OVERVIEW

### Introduction

Atropine is a natural alkaloid anticholinergic agent that has potent antimuscarinic effects and is used by injection to treat symptomatic bradycardia, severe bronchospasm and to reduce vagal stimulation. Atropine has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Atropine (at' roe peen) is a natural alkaloid that is the prototypic anticholinergic agent found as a secondary metabolite in plants of the Solanaceae family, including deadly nightshade (Atropa belladonna) for which it is named. Atropine has potent and broad, nonspecific antimuscarinic activity. Because of its rapid onset of action and short half-life, atropine is used parenterally in management of medical emergencies including cardiac bradyarrhythmias, during anesthesia to prevent vagal reflexes and to decrease secretions, for acute bronchospasm, and for anticholinesterase overdose or poisoning. Oral formulations of atropine are present in many over the counter and combination products used for allergic rhinitis and symptoms of peptic ulcer disease. Atropine has been in use in medicine for decades, but has not been formally approved for many of its broadly accepted indications. Atropine is used in low doses (1 mg or less) and usually for short periods of time. Homatropine (hoe mat' roe peen) is a synthetic derivative of atropine and is less potent and has a shorter half-life, which makes it appropriate as a cycloplegic eye drops to dilate the pupils. It is also used in combination with opiate drugs for its aversive side effects to prevent abuse of high doses. Common side effects of atropine are those of parasympathetic stimulation and include dryness of the mouth and eyes, decreased sweating, hyperthermia, headache, visual blurring, constipation, urinary retention, impotence, tachycardia and palpitations, anxiety, restlessness and in some instances agitation and hallucinations. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Despite widespread use over many decades, atropine has not been linked convincingly to episodes of liver enzyme elevations or clinically apparent liver injury. Atropine is metabolized by the liver, but is usually given in low doses (<1 mg) for short periods only.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on the Anticholinergic Agents.

Drug Class: Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atropine – Generic

Homatropine – Generic

DRUG CLASS

Anticholinergic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Atropine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Atropine | 51-55-8 | C17-H23-N-O3 | Atropine Chemical Structure
Homatropine | 87-00-3 | C16-H21-N-O3 | Homatropine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Atropine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Atropine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Atropine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Atropine)